# Anakinra

## OVERVIEW

### Introduction

Anakinra is a recombinant interleukin-1 (IL-1) receptor antagonist that has antiinflammatory and immunomodulatory actions and is used in the therapy of rheumatoid arthritis and other inflammatory arthritides. Anakinra is associated with a low rate of serum enzyme elevations during therapy and with rare instances of clinically apparent, acute liver injury.

### Background

Anakinra (an a kin’ ra) is used to treat serious inflammatory conditions such as rheumatoid arthritis and cryopyrin-associated periodic syndromes (CAPS). IL-1 like tumor necrosis factor alpha (TNF) is a proinflammatory cytokine that plays a major role in the immune responses underlying local and systemic inflammation. IL-1 also is the dominant cartilage destructive cytokine. Circulating IL-1 receptor antagonists (IL-1Ra) modulate the effects of IL-1 and are synthesized in response to inflammatory reactions, acting to prevent binding of circulating IL-1 to its receptor and thus helping to terminate the proinflammatory reaction. Anakinra is a recombinant version of IL-1Ra produced in E. coli, differing from the natural cytokine antagonist only in being nonglycosylated and having the addition of a single amino acid (methionine) on its amino terminus. Anakinra has been shown to be a disease modifying antirheumatologic drug (DMARD) and to improve signs and symptoms and decrease cartilage destruction in rheumatoid arthritis. Anakinra was approved for use in the United States in 2001 and its current formal indications are for severe rheumatoid arthritis and the autoinflammatory conditions known as cryopyrin-associated periodic syndromes (CAPS). It is used off label for idiopathic juvenile arthritis and other autoimmune forms of arthritis such as adult onset Still disease and macrophage activation syndrome. Anakinra must be given parenterally daily and is available under the brand name Kineret in prefilled syringes of 100 mg per 0.67 mL, which allow for doses between 20 and 100 mg. A typical regimen is 100 mg subcutaneously each day. Common side effects are local skin reactions, gastrointestinal upset, headache, arthralgias and possibly an increased incidence of bacterial infections. Less common but potentially severe adverse reactions include serious infections, reactivation of tuberculosis and hypersensitivity reactions.

### Hepatotoxicity

In large registration trials, ALT elevations occurred in <1% of patients taking anakinra, a rate not different from that in placebo recipients, and no cases of clinically apparent liver injury with jaundice were reported. Since its approval and more wide scale use, however, anakinra has been linked to several instances of acute liver injury. The onset was within a few weeks to up to 6 months after starting subcutaneous injections of anakinra and the typical clinical presentation resembled acute viral hepatitis, with a hepatocellular pattern of serum enzyme elevations, high levels of ALT and AST and mild to moderate jaundice. Immunoallergic features were not reported and autoantibodies were considered due to the underlying conditions being treated. Liver biopsies demonstrated an acute hepatocellular injury with prominence of eosinophils. Most patients recovered within 2 to 8 weeks of stopping anakinra without evidence of residual injury, but some cases have been severe, protracted and associated with transient features of hepatic failure. Not all published cases of anakinra-associated acute liver injury have been very convincing; virtually all have occurred in patients with Still's disease in which acute liver injury can be a manifestation of the underlying condition or a component of macrophage activation syndrome, a potentially life-threatening complication of adult onset Still’s disease and other inflammatory arthritides. Furthermore, in many of the published instances, patients were taking other drugs capable of causing acute liver injury (such as high dose methylprednisolone). Anakinra has not been linked to reactivation of hepatitis B or exacerbation of chronic hepatitis C.

Likelihood score: C (probable cause of clinically apparent acute liver injury).

### Mechanism of Injury

Anakinra binds to circulating IL-1 and is metabolized peripherally, probably largely in macrophages. It is a polypeptide and has minimal hepatic metabolism. The mechanism by which it causes liver injury is unknown, but may be the result of its effects on the immune system.

### Outcome and Management

The hepatic injury caused by anakinra is usually self-limited and resolves within a few weeks of stopping the medication, although some cases have been severe and protracted. Cases of fatal, acute liver failure, chronic hepatitis and vanishing bile duct syndrome have not been reported with its use. There is no reason to suspect that there may be cross sensitivity to hepatic injury between anakinra and other immune modulating biologic agents including agents that modulate IL1 such as canakinumab and rilonacept.

Drug Class: Antirheumatic Agents

Other Drugs in the Subclass, Interleukin Receptor Antagonists: Canakinumab, Rilonacept, Sarilumab, Tocilizumab

## CASE REPORT

### Case 1. Acute liver injury due to anakinra.(1)

A 22 year old woman with suspected adult onset Still disease was treated with anakinra, which resulted in a marked improvement in the inflammatory arthritis, but was followed by the development of jaundice 3 weeks after starting the daily injections. Before starting anakinra, the patient had presented with a systemic inflammatory condition marked by fever, skin rash and polyarthritis that was diagnosed as being adult onset Still disease, based upon the clinical presentation and laboratory findings of an elevated erythrocyte sedimentation rate and serum ferritin in the absence of autoantibodies or rheumatoid factor. She was treated with high doses of methylprednisolone followed by oral prednisone (1 mg/kg) with little change in symptoms, and persistent fever and arthralgias. Anakinra was started in a subcutaneous dose of 100 mg daily, which was followed by symptomatic improvement and fall of ESR to normal within a week. The dose of prednisone was decreased to 30 mg daily and anakinra was continued. Three weeks after starting the IL-1ra therapy she developed fatigue and jaundice. She had no previous history of liver disease, alcohol abuse or risk factors for viral hepatitis. When she initially presented with fever and polyarthritis, serum aminotransferase levels were mildly elevated. At the time of presentation with jaundice, the serum total bilirubin was 6.8 mg/dL (6.6 direct), ALT 3346 U/L, AST 2386 U/L, GGT 538 U/L and alkaline phosphatase 300 U/L. Tests for hepatitis A, B and C were negative and abdominal ultrasound was normal, with no evidence of biliary obstruction. A liver biopsy showed an acute hepatitis with marked inflammation and necrosis without fibrosis or signs of hemophagocytosis. Stopping anakinra was followed by a rapid improvement in the liver injury, but two weeks later the reappearance of symptoms and signs of adult onset Still disease prompted treatment with intravenous immunoglobulin which led to a remission in disease.

#### Key Points

Medication: | Anakinra (100 mg daily)
Pattern: | Hepatocellular (R=32)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 3 weeks
Recovery: | ~2 weeks
Other medications: | Prednisone, folate

#### Comment

This patient developed acute hepatitis with jaundice 3 weeks after starting daily doses of anakinra for adult onset Still's disease. The pattern and course of the liver injury was quite typical of idiosyncratic drug induced liver injury and compatible with the type of injury that has been reported with anakinra with a 2 to 6 week latency and a hepatocellular or mixed pattern of liver enzyme elevations. The pathogenesis is unknown. Anakinra is a recombinant protein and is unlikely to be inherently hepatotoxic, but rather more likely to toe trigger the acute liver injury indirectly by its action against IL-1 or on the immune system. Patients with adult onset Still disease often have hepatic involvement and particularly with the complication of macrophage activation syndrome, marked by immune activation and proliferation of cytotoxic CD8 T cells and macrophages with hemophagocytosis. However, in this case there was no evidence of concurrent hemophagocytosis or macrophage activation.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Anakinra – Kineret®

DRUG CLASS

Antirheumatic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=anakinra)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Anakinra | 143090-92-0 | C759-H1186-N208-O232-S10 | Protein

## CITED REFERENCE

1 Diallo A, Mekinian A, Boukari L, Mouas H, Zamy M, Nahon P, Gérin M, et al. (2013). Rev Med Interne.

## ANNOTATED BIBLIOGRAPHY

References updated: 20 April 2020

Abbreviations: IL-1ra, interleukin 1 receptor antagonist; CAPS, cryopyrin-associated periodic syndromes; TNF, tumor necrosis factor; IVIG, intravenous immunoglobulin.

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-53. (Expert review of hepatotoxicity published in 1999 before the availability of anakinra).
Krensky AM, Azzi JR, Hafler DA. Immunosuppressants and tolerogens. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 637-53. (Textbook of pharmacology and therapeutics).
Bywaters EG. (1971). Still's disease in the adult. Ann Rheum Dis. (Clinical description of 14 patients with adult onset Still disease seen at a single referral center in the UK over a 25 year period; all woman, ages 17-35 years, presenting with urticarial, macular rash, high fevers, fatigue and arthritis, high ESR but no rheumatoid factor, the majority ultimately recovering completely without residual arthritis or problems).
Bresnihan B, Alvaro-Gracia JM, Cobby M, Doherty M, Domljan Z, Emery P, Nuki G, et al. (1998). Treatment of rheumatoid arthritis with recombinant human interleukin-1 receptor antagonist. Arthritis Rheum. (Among 472 patients with rheumatoid arthritis enrolled in a controlled trial comparing anakinra [30, 75 or 150 mg] vs placebo, both given subcutaneously once daily for 24 weeks, the most frequent side effect was injection site reactions [50%-81% vs 25% with placebo]; "no other important adverse effects were detected in the laboratory analyses").
Nuki G, Bresnihan B, Bear MB, McCabe D, European Group Of Clinical Investigators. (2002). Long-term safety and maintenance of clinical improvement following treatment with anakinra(recombinant human interleukin-1 receptor antagonist) in patients with rheumatoid arthritis; extension phase of a randomized, double-blind, placebo-controlled trial. Arthritis Rheum. (Among 309 patients with rheumatoid arthritis who entered an extension phase after a controlled trial of anakinra [Bresnihan 1998] and were treated for up to 76 weeks, the only common adverse event being injection site reactions; no mention of ALT elevations or clinically apparent liver injury).
Fleischmann RM, Schechtman J, Bennett R, Handel ML, Burmester GR, Tesser J, Modafferi D, et al. (2003). Anakinra, a recombinant human interleukin-1 receptor antagonist(r-metHuIL-1ra), in patients with rheumatoid arthritis: A large, international, multicenter, placebo-controlled trial. Arthritis Rheum. (Among 1414 patients with rheumatoid arthritis treated for 24 weeks with anakinra [100 mg] or placebo given subcutaneously once daily, serum biochemistry testing indicated "no evidence of hepatotoxicity").
Andrès E, Kurtz JE, Perrin AE, Pflumio F, Ruellan A, Goichot B, Dufour P, et al. (2003). Retrospective monocentric study of 17 patients with adult Still's disease, with special focus on liver abnormalities. Hepatogastroenterology. (Among 17 patients with adult onset Still disease seen at a single French referral center, mean age was 27 years and 76% had "moderate liver dysfunction" with hepatomegaly in 47%, bilirubin 0.6-1.3 mg/dL, ALT 32-252 U/L; all ultimately had "complete recovery").
Hawkins PN, Lachmann HJ, McDermott MF. (2003). Interleukin-1-receptor antagonist in the Muckle-Wells syndrome. N Engl J Med. (Two patients with Muckle-Wells syndrome, a hereditary autoinflammatory disease, had a dramatic and sustained response to therapy with anakinra).
Furst DE. (2004). Anakinra: review of recombinant human interleukin-I receptor antagonist in the treatment of rheumatoid arthritis. Clin Ther. (Systematic review of literature on anakinra therapy of rheumatoid arthritis concluded that it was "mildly to moderately effective and well tolerated", the frequency of side effects other than injection site reactions being no different than that among placebo recipients).
Fleischmann RM, Tesser J, Schiff MH, Schechtman J, Burmester GR, Bennett R, Modafferi D, et al. (2006). Safety of extended treatment with anakinra in patients with rheumatoid arthritis. Ann Rheum Dis. (Summary of an open label extension trial of anakinra in 1346 patients with rheumatoid arthritis who had participated in a randomized controlled trial [Fleischmann 2002], mentions that 5 patients [0.4%] had elevated serum enzymes, but no details of levels or outcomes given; among 15 deaths, there were none attributed to liver disease).
Efthimiou P, Georgy S. (2006). Pathogenesis and management of adult-onset Still's disease. Semin Arthritis Rheum. (Adult onset Still disease is a rare, systemic inflammatory disorder of unknown cause characterized by fever, distinctive skin rash, arthritis and multiorgan involvement).
Kötter I, Wacker A, Koch S, Henes J, Richter C, Engel A, Günaydin I, Kanz L. (2007). Anakinra in patients with treatment-resistant adult-onset Still's disease: four case reports with serial cytokine measurements and a review of the literature. Semin Arthritis Rheum. (Description of 4 patients with chronic or relapsing adult onset Still disease who had an immediate, dramatic response to anakinra therapy, having failed to respond to corticosteroids, methotrexate, TNF antagonists and leflunomide; ALT and AST values improved with treatment as well).
Mylona E, Golfinopoulou S, Samarkos M, Fanourgiakis P, Papadakos V, Skoutelis A. (2008). Acute hepatitis in adult Still's disease during corticosteroid treatment successfully treated with anakinra. Clin Rheumatol. (46 year old man with adult onset Still disease developed worsening liver tests during prednisone taper [bilirubin 1.5 mg/dL, ALT 3009 U/L, Alk P 185 U/L, INR normal] that improved when anakinra was added, with remission in disease and fall of all liver tests into the normal range).
Mertens M, Singh JA. (2009). Anakinra for rheumatoid arthritis: a systematic review. J Rheumatol. (Systematic review of literature on efficacy and safety of anakinra in rheumatoid arthritis identified 5 clinical trials involving 2846 patients; the major adverse events were injection site reactions [71% vs 28% with placebo], nonsignificant increase in serious infections, but no mention of liver injury or ALT elevations).
Canna S, Frankovich J, Higgins G, Narkewicz MR, Nash SR, Hollister JR, Soep JB, et al. (2009). Acute hepatitis in three patients with systemic juvenile idiopathic arthritis taking interleukin-1 receptor antagonist. Pediatr Rheumatol Online J. (Description of 3 patients with systemic juvenile rheumatoid arthritis who developed symptomatic hepatitis 1-8 months after starting anakinra [bilirubin not given, AST ~1200 to 3000 U/L], resolving once anakinra was stopped).
Zhu G, Liu G, Liu Y, Xie Q, Shi G. (2009). Liver abnormalities in adult onset Still's disease: a retrospective study of 77 Chinese patients. J Clin Rheumatol. (Retrospective analysis of clinical features of 77 patients with adult onset Still disease presenting at a single referral center in China reported hepatomegaly in 12%, ALT or AST elevations in 62%, values >5 times ULN in 16% [some on therapy], hepatitis with jaundice in 8%; 2 patients developed acute liver failure and one died, the rest recovered without residual injury).
Furst DE. (2010). The risk of infections with biologic therapies for rheumatoid arthritis. Semin Arthritis Rheum. (Review of the excess risk of infections during biologic therapy of rheumatoid arthritis mentions that infection was 2.1% in anakinra treated patients vs 0.4% in controls; infections were primarily pneumonia and skin infections, none were fatal and few were opportunistic).
Hot A, Toh ML, Coppéré B, Perard L, Madoux MH, Mausservey C, Desmurs-Clavel H, et al. (2010). Reactive hemophagocytic syndrome in adult-onset Still disease: clinical features and long-term outcome: a case-control study of 8 patients. Medicine (Baltimore). (Among 8 patients with adult onset Still’s disease and “reactive hemophagocytic syndrome [now referred to as macrophage activation syndrome], ages 22 to 75 years, 6 women, 2 men, with onset of syndrome at time of diagnosis of Still’s disease in most, characterized by rash, fever, lymphopenia, lymphadenopathy, pharyngitis, arthralgia, abnormal liver tests [bilirubin elevated in 2, ALT in all, 46 to 388 U/L, high ferritin, low fibrinogen], achieving a remission ultimately on immunosuppression with corticosteroids, with or without IVIG, methotrexate, cyclophosphamide or cyclosporin).
Mahamid M, Paz K, Reuven M, Safadi R. (2011). Hepatotoxicity due to tocilizumab and anakinra in rheumatoid arthritis: two case reports. Int J Gen Med. (49 year old woman with rheumatoid arthritis and nonalcoholic fatty liver disease developed fatigue and mild serum enzyme elevations 2 months after starting anakinra [bilirubin normal, ALT 50 U/L, Alk P 161 U/L], resolving rapidly upon stopping).
Mahamid M, Mader R, Safadi R. Hepatotoxicity of tocilizumab and anakinra in rheumatoid arthritis: management decisions. Clin Pharmacol 2011; 3:3 9-43. (Description of same two patients as in Mahamid [Int J Gen Med 2011]).
Carroll MB. (2011). The impact of biologic response modifiers on hepatitis B virus infection. Expert Opin Biol Ther. (Review of reactivation of hepatitis B by biologic response modifiers; anakinra has not been linked to reactivation of HBV, either in the published literature or in reports to the sponsor).
Lim KB, Schiano TD. (2011). Still disease and the liver-an underappreciated association. Gastroenterol Hepatol (N Y). (Concise review of liver dysfunction in adult-onset Still's disease which can vary from asymptomatic ALT elevations to acute liver failure and diagnosis of superimposed drug induced liver injury [from anakinra, methotrexate, penicillamine, leflunomide or cyclophosphamide among others] is often difficult).
Nigrovic PA, Mannion M, Prince FH, Zeft A, Rabinovich CE, van Rossum MA, Cortis E, et al. (2011). Anakinra as first-line disease-modifying therapy in systemic juvenile idiopathic arthritis: report of forty-six patients from an international multicenter series. Arthritis Rheum. (Retrospective analysis of 46 patients with juvenile idiopathic arthritis treated with anakinra at 11 referral centers in 4 countries; clinical responses occurred in more than 95% of patients, often within the first month; one 8 year old child developed acute hepatitis [described in Canna 2009] and two other patients had elevations in serum enzymes on treatment, but no details given).
Rubbert-Roth A. (2012). Assessing the safety of biologic agents in patients with rheumatoid arthritis. Rheumatology (Oxford). (Overview of safety of biologic agents in rheumatoid arthritis mentions that anakinra has not been associated with reactivation of tuberculosis, and the incidence of malignancies is not increased with its use; no mention of ALT elevations or hepatotoxicity).
Dinarello CA, Simon A, van der Meer JW. (2012). Treating inflammation by blocking interleukin-1 in a broad spectrum of diseases. Nat Rev Drug Discov. (Review of the biologic actions of IL-1 and the clinical efficacy and safety of agents that block its activity including anakinra [IL-1Ra], canakinumab [monoclonal antibody to IL-1 beta] and rilonacept [recombinant soluble IL-1 receptor]).
(2012). Drugs for rheumatoid arthritis. Treat Guidel Med Lett. (Concise summary on current therapies of rheumatoid arthritis states that anakinra is considered the least effective biologic DMARD and is not recommended).
Miyamae T. (2012). Cryopyrin-associated periodic syndromes: diagnosis and management. Paediatr Drugs. (Review of the clinical features, pathogenesis and therapy of CAPS with specific discussion of anakinra, rilonacept and canakinumab; no mention of hepatotoxicity).
Moran A, Bundy B, Becker DJ, DiMeglio LA, Gitelman SE, Goland R, Greenbaum CJ, et al. (2013). Type 1 Diabetes TrialNet Canakinumab Study Group; AIDA Study Group. Interleukin-1 antagonism in type 1 diabetes of recent onset: two multicentre, randomised, double-blind, placebo-controlled trials. Lancet. (Two parallel trials comparing anakinra or canakinumab to placebo in 69 patients with recent onset of type 1 diabetes found no evidence of benefit and similar side effects of both drugs; no mention of ALT elevations or hepatotoxicity).
Akgul O, Kilic E, Kilic G, Ozgocmen S. (2013). Efficacy and safety of biologic treatments in Familial Mediterranean Fever. Am J Med Sci. (Systematic review of reports on biologic response modifiers in Familial Mediterranean Fever identified no controlled trial, but 24 single reports and 7 case series describing 59 patients, 35 on anti-TNF agents, 29 anakinra, 4 canakinumab; 2 had adverse events that required stopping but the rest seemed to have a beneficial effect; no discussion of hepatotoxicity).
Diallo A, Mekinian A, Boukari L, Mouas H, Zamy M, Nahon P, Gérin M, et al. (2013). Rev Med Interne. (22 year old woman with adult onset Still disease developed jaundice 3 weeks after starting anakinra which had induced a remission in disease [bilirubin 6.8 mg/dL, ALT 3346 U/L, Alk P 300 U/L], improving promptly when anakinra was stopped: Case 1).
Aly L, Iking-Konert C, Quaas A, Benten D. (2013). Subacute liver failure following anakinra treatment for adult-onset Still disease. J Rheumatol. (20 year old man with adult onset Still disease developed fever and jaundice 3 months after starting anakinra and prednisone [bilirubin ~10 mg/dL, ALT ~4000 U/L, INR 2.7], with splenomegaly and ascites, improving upon stopping anakinra and increasing prednisone with eventual resolution 5 months after onset).
Néel A, Henry B, Barbarot S, Masseau A, Perrin F, Bernier C, Kyndt X, et al. (2014). Long-term effectiveness and safety of interleukin-1 receptor antagonist (anakinra) in Schnitzler's syndrome: a French multicenter study. Autoimmun Rev. (Among 42 patients with Schnitzler's syndrome followed in 16 centers in France, 29 were treated with anakinra, all of whom had marked improvements on therapy which were maintained during an average follow up of 3 years; side effects included injection site reactions [17%], neutropenia [10%], infections [21: mostly pneumonia, 2 being fatal] and colon cancer [1 case]; no mention of hepatotoxicity or ALT elevations and no discontinuations for liver related complications),
Ahmed O, Brahmania M, Alsahafi M, Alkhowaiter S, Erb S. (2015). Anakinra hepatotoxicity in a patient with adult-onset Still's disease. ACG Case Rep J. (46 year old woman with adult-onset Still's disease developed ALT elevations 2 weeks after starting anakinra [bilirubin 1.2 mg/dL, ALT 1202 U/L, Alk P not given], with worsening of liver injury one week after restarting anakinra [bilirubin 6.7 mg/dL, ALT 1945 U/L, GGT 696 U/L] which gradually resolved on stopping and did not recur on subsequent therapy with etanercept).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, no cases were attributed to anakinra or other interleukin 1 receptor antagonists).
Kullenberg T, Löfqvist M, Leinonen M, Goldbach-Mansky R, Olivecrona H. (2016). Long-term safety profile of anakinra in patients with severe cryopyrin-associated periodic syndromes. Rheumatology (Oxford). (Among 43 patients with severe cryopyrin-associated periodic syndromes [84% <18 years of age] treated with anakinra for up to 5 years, adverse events were common but mostly due to the underlying condition; 14 patients [33%] had a serious adverse event, but none were liver related and there was no mention of ALT elevations or hepatotoxicity).
Taylor SA, Vittorio JM, Martinez M, Fester KA, Lagana SM, Lobritto SJ, Ovchinsky N. (2016). Anakinra-induced acute liver failure in an adolescent patient with Still's disease. Pharmacotherapy. (19 year old man with Still's disease developed serum ALT and AST elevations 16 days after starting high dose methylprednisone and 5 days after starting anakinra [direct bilirubin 1.7 mg/dL, ALT rising from 19 to 2002 U/L, Alk P not given, INR 1.7], biopsy showing acute hepatitis and liver test abnormalities, resolving within 30 days of stopping anakinra and switching iv methylprednisolone to oral prednisone).
Lenert A, Yao Q. (2016). Macrophage activation syndrome complicating adult onset Still's disease: A single center case series and comparison with literature. Semin Arthritis Rheum. (Description of 7 patients with adult onset Still’s disease who developed macrophage activation syndrome soon after initial presentation manifested by fever, rash, arthralgias, lymphopenia, leukocytosis and liver test abnormalities [mean bilirubin 4.2 mg/dL, ALT 290 U/L, LDH 2167 U/L, INR 1.58], and variable degrees of renal and pulmonary failure and hemophagocytosis present in 3 of 7 bone marrow biopsies, with excellent response to anakinra).
Colafrancesco S, Priori R, Valesini G, Argolini L, Baldissera E, Bartoloni E, Cammelli D, et al. (2017). Response to interleukin-1 inhibitors in 140 Italian patients with adult-onset Still's disease: a multicentre retrospective observational study. Front Pharmacol. (Among 140 patients with adult onset Still’s disease followed at 18 Italian referral centers treated with anakinra, clinical responses were common and the most frequent adverse events were local injection reactions, rash and infections [15%] while hepatomegaly and liver test abnormalities decreased on treatment (from 47% to 5%]; therapy was switched to canakinumab in 4 patients with an unsatisfactory response to anakinra and 3 responded and “no adverse events were registered”).
Ruperto N, Brunner HI, Quartier P, Constantin T, Wulffraat NM, Horneff G, Kasapcopur O, et al., Paediatric Rheumatology International Trials Organisation (PRINTO) and the Pediatric Rheumatology Collaborative Study Group (PRCSG). (2018). Canakinumab in patients with systemic juvenile idiopathic arthritis and active systemic features: results from the 5-year long-term extension of the phase III pivotal trials. Ann Rheum Dis. (Among 144 children with juvenile idiopathic arthritis enrolled in controlled trials [Ruperto 2012] who were continued on therapy in extension studies, 102 discontinued treatment because of lack of efficacy while clinical efficacy was maintained in the rest, adverse events included macrophage activation syndrome [6%], hepatitis [1%] and hepatic enzyme elevations [2%]).
Sota J, Vitale A, Insalaco A, Sfriso P, Lopalco G, Emmi G, Cattalini M, et al. (2018). “Working Group” of Systemic Autoinflammatory Diseases of SIR (Italian Society of Rheumatology). Safety profile of the interleukin-1 inhibitors anakinra and canakinumab in real-life clinical practice: a nationwide multicenter retrospective observational study. Clin Rheumatol. (Among 475 patients treated with anakinra or canakinumab for various inflammatory conditions for an average of 24 months, the most frequently reported adverse events were rash, injection site reactions, infections, cytopenias, and anaphylaxis; one patient developed serum enzyme elevations and one macrophage activation syndrome).
Giacomelli R, Ruscitti P, Shoenfeld Y. (2018). A comprehensive review on adult onset Still's disease. J Autoimmun. (Review of the pathogenesis, clinical features, complications and therapy of adult onset Still’s disease mentions that liver test abnormalities have been reported in 21-61% of subjects and that anakinra has been studied in at least 13 small open label trials with response rates of 46-100% and tocilizumab in 8 trials with response rates of 65-100%).
Crayne CB, Albeituni S, Nichols KE, Cron RQ. (2019). The Immunology of macrophage activation syndrome. Front Immunol. (Review of the immunopathogenesis of the macrophage activation syndrome, a complication of several systemic inflammatory disorders including juvenile idiopathic arthritis, systemic lupus erythematosus and adult onset Still’s disease, characterized by high circulating levels of proinflammatory cytokines which has led to the experimental use of cytokine inhibitors such as anakinra).
Vastert SJ, Jamilloux Y, Quartier P, Ohlman S, Osterling Koskinen L, Kullenberg T, et al. (2019). Anakinra in children and adults with Still's disease. Rheumatology (Oxford). (Review of the mechanism of action, clinical efficacy and safety of anakinra in pediatric and adult-onset Still’s disease with summary of 27 publications reporting response rates of 23-81% usually with complete remission and ability to stop or decrease corticosteroid use; mentions that liver injury attributed to anakinra has been reported).

## OTHER REFERENCE LINKS

1 Recent References on Anakinra: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Anakinra+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Anakinra: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Anakinra)